# Difelikefalin

## OVERVIEW

### Introduction

Difelikefalin is a synthetic tetrapeptide agonist of the kappa opioid receptor that is used to treat pruritus in adults with chronic kidney disease undergoing hemodialysis. Difelikefalin has not been associated with serum enzyme elevations during therapy or with episodes of clinically apparent liver injury.

### Background

Difelikefalin (dye fel” i kef’ a lin) is a synthetic, D-amino acid tetrapeptide agonist of the kappa opioid receptor that is involved in sensory pathways causing pruritus. Pruritus is common in persons with end-stage renal disease and can be severe and have adverse effects on quality of life. Approximately 60% of patients with chronic renal disease on hemodialysis have pruritus which is moderate-to-severe in 20% to 40%. Medications typically used for itching such as skin creams, antihistamines, gabapentin, and corticosteroids, are only partially effective and can be associated with further troublesome symptoms. The cause of pruritus in chronic renal failure is not well defined, but an imbalance of kappa and mu opioid activity appears to play a role. Difelikefalin is a specific agonist of the kappa opioid receptor which has been shown to decrease scratching behavior in animal models. In several randomized, placebo controlled trials, difelikefalin given intravenously at the end of hemodialysis sessions 3 times weekly was shown to decrease itching scores significantly in at least 40% of patients. Long term treatment led to improvements in quality of life in a proportion of patients. Difelikefalin was approved for use in the United States in 2021 and is available under the brand name Korsuva in solution in single use vials of 65 μg/1.3 mL (50 μg/mL). The recommended dose regimen in adults is 0.5 μg/kg given intravenously at the end of each hemodialysis session (usually 3 times weekly). It has not been approved as therapy of itching in patients on peritoneal dialysis, or those with chronic renal disease not on dialysis, or in other conditions associated with moderate-to-severe pruritus. However, both intravenous and an oral formulation of difelikefalin are under evaluation as therapy of pruritus due to other conditions (atopic dermatitis, primary biliary cholangitis). Therapy is generally well tolerated but side effects can include diarrhea, nausea, dizziness, headache, somnolence, gait disturbance, falls, and changes in mental status. Despite being an opioid receptor agonist, difelikefalin has no abuse potential and does not cause psychological or physical dependence. Severe adverse events include daytime somnolence with gait disturbances, falls, and impairment in driving and operation of heavy machinery.

### Hepatotoxicity

In registration trials of difelikefalin, elevations in serum liver-associated enzyme levels were uncommon and no more frequent than in controls. Serum alkaline phosphatase elevations occurred in 12.7% vs 12.0% of participants, and there were no ALT elevations above 3 times the upper limit of normal (ULN). Since approval and more widespread use of difelikefalin, there have been no published reports of hepatotoxicity attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which difelikefalin might cause liver injury is unknown. It is a tetrapeptide and is not metabolized by the cytochrome P450 system. It has no significant drug-drug interactions other than contribution to excess somnolence and changes in mental status in persons also receiving antidepressants or other sedating medications. The lack of liver injury from difelikefalin may be due, in part, to the low doses used, generally in microgram amounts and well below 1 mg daily.

### Outcome and Management

There is little evidence that difelikefalin causes serum enzyme elevations or liver injury. It has not been evaluated in patients with advanced liver disease and is not recommended in patients with decompensated cirrhosis (Child Pugh scores of B or C). Because difelikefalin is an opioid receptor agonist and can induce somnolence, it may like other opioid agonists cause or worsen hepatic encephalopathy in patients with moderate or severe liver dysfunction.

Drug Class: Renal Disease Agents

Other Drugs for Pruritus: Antihistamines, Corticosteroids, Gabapentin, Rifampin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Difelikefalin – Korsuva®

DRUG CLASS

Renal Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Difelikefalin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Difelikefalin | 1024828-77-0 | C36-H53-N7-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2025

Zimmerman HJ. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before availability of difelikefalin).
Sewell MJ, Burkhart C, Morrell D. Dermatological pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2021. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214916Orig1s000MultidisciplineR.pdf (FDA website with product labels and clinical review of the data on efficacy and safety submitted by the sponsor in support of approval for difelikefalin in the US; among 851 patients in two randomized, placebo controlled trials of difelikefalin, common side effects included diarrhea, nausea, dizziness, gait disturbance, falls, hypokalemia, headache, somnolence, and changes in mental status, while alkaline phosphatase elevations arose in 12.7% vs 12.0% but no patient had ALT elevations above 3 times ULN or liver enzyme elevations with jaundice).
Fishbane S, Jamal A, Munera C, Wen W, Menzaghi F; KALM-1 Trial Investigators. A phase 3 trial of difelikefalin in hemodialysis patients with pruritus. N Engl J Med. 2020;382:222-232. (Among 378 adults with chronic renal disease on hemodialysis with moderate-to-severe pruritus treated with difelikefalin [0.5 mcg/kg] or placebo at the end of each dialysis session 3 times weekly for 12 weeks, symptom scores for pruritus decreased more frequently with difelikefalin [37% vs 18%], while adverse events were more frequent [69% vs 62%], mostly due to diarrhea, dizziness, nausea, and vomiting; no mention of ALT elevations or hepatotoxicity). 31702883
Steele DJR. Difelikefalin for the treatment of uremic pruritus. N Engl J Med. 2020;382:289-290. (Editorial in response to publication by Fishbane [2020]). 31940704
Deeks ED. Difelikefalin: first approval. Drugs. 2021;81:1937-1944. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of difelikefalin shortly after its approval in the US, discusses common side effects but does not mention ALT elevations or hepatotoxicity). 34674115
Difelikefalin (Korsuva) for chronic kidney disease-associated pruritus. Med Lett Drugs Ther. 2022;64:18-19. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of difelikefalin shortly after its approval for use in the US, discusses common side effects; no mention of ALT elevations or hepatotoxicity). 35134047
Fishbane S, Wen W, Munera C, Lin R, Bagal S, McCafferty K, Menzaghi F, et al. Safety and tolerability of difelikefalin for the treatment of moderate to severe pruritus in hemodialysis patients: pooled analysis from the phase 3 clinical trial program. Kidney Med. 2022;4:100513. (In a pooled analysis of two randomized, placebo controlled trials of difelikefalin in adults with chronic kidney disease on hemodialysis with moderate-to-severe pruritus, side effects more frequent with drug were diarrhea [9% vs 5.7%], dizziness [6.8% vs 3.8%], nausea [6.6% vs 4.5%], gait disturbance [6.6% vs 5.4%], headache [4.5% vs 2.6%], somnolence [4.2% vs 2.4%], and mental status changes [3.3% vs 1.4%]; no mention of ALT elevations or hepatotoxicity). 36039153
Yosipovitch G, Awad A, Spencer RH, Munera C, Menzaghi F. A phase 2 study of oral difelikefalin in subjects with chronic kidney disease and moderate-to-severe pruritus. J Am Acad Dermatol. 2023;89:261-268. (Among 269 adults with chronic kidney disease and moderate-to-severe pruritus treated with oral difelikefalin [0.25, 0.5, and 1.0 mg] or placebo daily for 12 weeks, a higher proportion of participants receiving the highest dose of difelikefalin [1.0 mg daily] had significant decreases in pruritus symptom scores [39% vs 14%], while adverse events were generally mild and “there were no clinically relevant abnormalities of laboratory values”). 37059302
Guttman-Yassky E, Facheris P, Da Rosa JC, Rothenberg-Lausell C, Del Duca E, David E, Estrada Y, et al. Oral difelikefalin reduces moderate to severe pruritus and expression of pruritic and inflammatory biomarkers in subjects with atopic dermatitis. J Allergy Clin Immunol. 2023;152:916-926. (Among 401 adults with atopic dermatitis and moderate-to-severe pruritus treated with oral difelikefalin [0.25, 0.5, or 1.0 mg] vs placebo once daily for 12 weeks, improvement in pruritus scores was only slightly better with drug, the results not reaching statistical significance; no mention of ALT elevations or hepatotoxicity). 37453614

## OTHER REFERENCE LINKS

1. Recent References on Difelikefalin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Difelikefalin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Difelikefalin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Difelikefalin)